# Amoxicillin-Clavulanate

## OVERVIEW

### Introduction

The combination of amoxicillin and clavulanate is an oral antibiotic widely used in the treatment of mild-to-moderate bacterial infections including sinusitis, bronchitis, otitis media, cellulitis and community acquired pneumonia. Amoxicillin-clavulanate is currently the most common cause of clinically apparent, drug induced acute liver injury both in the United States and Europe.

### Background

The combination of amoxicillin (a mox” i sil' in) and clavulanate (klav’ ue lan’ ate) is a commonly used antibiotic which is active against many bacterial organisms that cause sinusitis, bronchitis, otitis media, skin and tissue infections, and community acquired pneumonia. The combination consists of amoxicillin which is a semisynthetic, third generation penicillin and clavulanate which is a beta lactam that acts as an inhibitor of beta lactamase, the major bacterial enzyme responsible for penicillin resistance. Amoxicillin-clavulanate was approved for use in the United States in 1984 and, currently, approximately 10 million prescriptions are filled yearly, making it one of the most common antibiotic regimens used. Current indications are for mild-to-moderate bacterial infections due to known or suspected penicillinase resistant gram positive or gram negative organisms. This combination is provided in multiple dose combinations, typically as 250 to 875 mg amoxicillin with 125 mg of clavulanate, given two to three times daily for 7 to 10 days. Amoxicillin-clavulanate is available in multiple generic formulations and under the brand name Augmentin. Side effects are usually mild and self-limited and can include diarrhea, nausea and vomiting, fatigue, headache, and rash. Rare but potentially serious adverse events include hypersensitivity reactions, anaphylaxis, severe skin rash, Stevens Johnson syndrome, C. difficile diarrhea, interstitial nephritis, neutropenia, aplastic anemia and thrombocytopenic purpura.

### Hepatotoxicity

Amoxicillin-clavulanate has been implicated in hundreds of cases of clinically apparent acute liver injury and is currently the most common cause of drug induced liver disease in most large case series from North and South America, Australia, and Europe. The onset of injury is typically a few days to as long as 8 weeks (average ~3 weeks) after initiation of therapy and often occurs after the course of antibiotic is completed, the delay being a few days to as long as six weeks. The onset is typically with fatigue, low grade fever, nausea, and abdominal pain, followed by pruritus and jaundice. The pattern of liver enzyme elevations is typically cholestatic with marked elevations in alkaline phosphatase and gamma glutamyl transpeptidase (Case 1). In some instances, aminotransferase levels are markedly elevated giving a mixed (Case 2) or hepatocellular pattern (Case 3), particularly in younger patients with earlier onset of injury. In children, amoxicillin-clavulanate hepatotoxicity is typically anicteric and presents with nausea, vomiting and abdominal pain rather than jaundice and itching. The pattern of serum enzyme elevations is also much more likely to be hepatocellular in children, but the course of illness is typically benign. Because the liver injury may present days or weeks after stopping therapy, the association of the liver injury with receipt of amoxicillin-clavulanate may be overlooked. Immunoallergic features (fever, rash, eosinophilia) can occur, but are not invariably present and are usually not prominent. Autoantibody formation is not common. Amoxicillin-clavulanate has been linked to rare instances of DRESS syndrome, Stevens-Johnson syndrome, and vanishing bile duct syndrome. The hepatic injury is idiosyncratic and is estimated to occur after ~1 in 2,000 prescriptions. The injury is more common in men than women, in the elderly, and after multiple courses. Genetic studies indicate a link with HLA types, particularly the extended haplotype: DRB1*15:01-DRB5*01:01-DQB1*06:02 and independently with HLA-A*02.01.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of amoxicillin-clavulanate hepatotoxicity is unknown, but is probably immunoallergic in origin. Allergic manifestations can occur and include rash, fever, arthralgias and eosinophilia. Several studies have reported an HLA Class II association with DRB1*15:01 and the extended haplotype DRB1*15:01-DRB1*01:01-DQB1*06:02. An independent HLA Class I association has also been made with HLA-A*02:01. Less common but also linked to a greater risk of injury from amoxicillin-clavulanate is HLA-B*15:01 and to two non-HLA genes, variants in PTPN22 and ERAP2. In contrast, amoxicillin liver injury has been linked only to HLA-A*02:01 and not to the other amoxicillin-clavulanate risk alleles. Indeed, the liver injury from the combination appears to be due to the clavulanate rather than amoxicillin, as reexposure to amoxicillin alone has not been associated with recurrence (Case 5), whereas reexposure to the combination is usually followed by a more rapid onset of a more severe hepatic injury, which can include prolonged cholestasis and development of cirrhosis. Other beta lactamase inhibitors (tazobactam and sulbactam) have not been reported to cause a similar hepatic injury, although it has been reported with other penicillins when combined with clavulanate (ticarcillin/clavulanate).

### Outcome and Management

The liver injury caused by amoxicillin-clavulanate is typically associated with jaundice and can be severe and prolonged (with jaundice lasting 4 to 24 weeks), but rarely results in lasting injury or death. Deaths due to amoxicillin-clavulanate hepatic injury have been described, but largely in patients with other comorbidities including cirrhosis or with multiple exposures. In addition, rare instances of prolonged cholestasis and vanishing bile duct syndrome have been reported after acute amoxicillin-clavulanate injury. Corticosteroids have been used in patients with marked or prolonged cholestasis, but their efficacy has not been shown and their use cannot be recommended routinely. Cholestyramine or ursodiol may help alleviate symptoms but probably do not speed recovery. Rechallenge with amoxicillin-clavulanate results in recurrence and should be avoided. Unintentional re-exposure is not uncommon and often results in liver injury with a shorter latency to onset and longer period of recovery. Severe recurrences including deaths have been reported. Re-exposure after amoxicillin-clavulanate associated liver injury to amoxicillin alone, on the other hand, is usually tolerated and without recurrence of liver injury.

Drug Class: Antiinfective Agents, Aminopenicillins

Other Drugs in the Subclass, Aminopenicillins: Ampicillin, Ampicillin-Sulbactam, Amoxicillin, Bacampicillin, Pivampicillin, Ticarcillin-Clavulanate

## CASE REPORTS

### Case 1. Cholestatic hepatitis from amoxicillin-clavulanate.(1)

A 75 year old man with a history of prostate cancer and regular alcohol use (2 to 3 drinks daily) was given amoxicillin-clavulanate (500 mg/125 mg) for chronic maxillary sinusitis. Because of persistent symptoms, the antibiotic was continued for 31 days. When seen in follow up two weeks later, he complained of jaundice and was admitted to the hospital for evaluation. He had symptoms of dark urine, weakness, and poor appetite. Blood test results showed a total bilirubin of 42.7 mg/dL, ALT 194 U/L, AST 107 U/L, and alkaline phosphatase 257 U/L. Tests for acute hepatitis A, B, C and E were negative. Ultrasound of the abdomen showed no evidence of biliary obstruction or gallstones. During the hospitalization he developed profound anemia and thrombocytopenia requiring blood and platelet transfusions, and was further treated with corticosteroids and cyclophosphamide. His serum bilirubin peaked at 48.8 mg/dL and remained elevated for several months while aminotransferase and alkaline phosphatase levels were only modestly elevated (Table). The prothrombin time was elevated (INR 1.4 to 1.6) transiently and he developed mild confusion that was believed to be due to hepatic encephalopathy; he was treated with lactulose. During the hospitalization he developed renal failure and required dialysis. A liver biopsy was performed and findings were consistent with amoxicillin-clavulanate hepatotoxicity. He was hospitalized for 2 months and required another several months to recover fully. However, when seen 4 months after onset of the jaundice, he was back to his usual state of health and had normal laboratory tests, including normal aminotransferase and alkaline phosphatase levels, normal serum bilirubin and creatinine, and normal hemoglobin and platelet counts.

#### Key Points

Medication: | Amoxicillin-clavulanate 500/125 mg thrice daily for 31 days
Pattern: | Cholestatic (R=1.9)
Severity: | 4+ (jaundice, hospitalization, thrombocytopenia and acute renal failure)
Latency: | 40 days, 9 days after stopping
Recovery: | Slowly over 4 months
Other medications: | Guaifenesin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
31 days | 0 | Amoxicillin-clavulanate stopped
40 days | 9 days | Jaundice
6 weeks | 2 weeks | 126 | 195 | 43.8 | Admission, platelets 2,000
7 weeks | 3 weeks | 58 | 165 | 48.6
2 months | 4 weeks | 59 | 248 | 48.8
| 5 weeks | 44 | 198 | 42.4 | Acute renal failure
| 7 weeks | 40 | 195 | 19.4 | Liver biopsy
3 months | 8 weeks | 40 | 267 | 7.4
3.5 months | 10 weeks | 47 | 242 | 3.6 | Discharged, platelets 376,000
5 months | 4 months | 11 | 81 | 0.6 | Creatinine 2.5
Normal Values | | <42 | <115 | <1.2

#### Comment

This case is an example of severe amoxicillin-clavulanate hepatotoxicity. Liver histology showed central lobular retention of bile with mixed infiltrates of lymphocytes, neutrophils and eosinophils in portal areas and in areas of focal spotty necrosis in the parenchyma. There was minimal steatosis, no fibrosis and no biliary damage or peribiliary fibrosis or edema. The findings were consistent with an acute drug induced intrahepatic cholestasis. The case was typical of amoxicillin-clavulanate hepatotoxicity in its onset 1 to 2 weeks after stopping therapy in an elderly man without other history or risk factors for liver or biliary disease. The severe thrombocytopenia and anemia were atypical, but similar nonhepatic manifestations of immunoallergic injury have been reported. The renal failure was due to bilirubin nephropathy which resolves when the liver disease improves but may require renal dialysis for a limited time. Important conditions to exclude were biliary obstruction due to malignancy or gallstone disease and viral hepatitis. Therapy should be limited to symptomatic management of pruritus and avoidance of further hepatic injury. Appropriate management calls for follow up documentation of resolution of liver injury. The patient should be warned to avoid any further exposure to amoxicillin-clavulanate. In view of the severity of the injury, use of amoxicillin alone might also be best avoided.

### Case 2. Mixed cholestatic-hepatocellular injury due to amoxicillin-clavulanate.(1)

A 52 year old man without major medical illnesses developed an upper respiratory infection and was given a 14-day course of amoxicillin-clavulanate. One and two months later, because of similar symptoms of fever and congestion, he was given a 2nd and 3rd 14-day course along with antihistamines and decongestants. Two weeks after the 3rd course of antibiotics, he developed abdominal pain, nausea, poor appetite, and itching, followed soon after by jaundice and dark urine. He was seen and blood tests revealed total bilirubin of 3.9 mg/dL with marked elevations in both ALT and alkaline phosphatase (Table). He was managed as an outpatient, did not undergo liver biopsy, and recovered symptomatically over the next few weeks. When seen one year later, he was asymptomatic and laboratory tests had returned to normal.

#### Key Points

Medication: | Amoxicillin-clavulanate 500/125 mg twice daily for 42 days
Pattern: | Mixed cholestatic-hepatocellular (R=2.3)
Severity: | 2+ (jaundice, never hospitalized)
Latency: | 58 days, 16 days after stopping
Recovery: | Six months after stopping
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
2 weeks | 0 | Amoxicillin-clavulanate stopped
4 weeks | 16 days | Nausea, jaundice, arthralgia
| 16 days | 879 | 731 | 3.9 | Albumin 4.3 g/dL
5 weeks | 3 weeks | 629 | 503 | 1.7
7 weeks | 5 weeks | 141 | 182 | 0.8
10 weeks | 8 weeks | 90 | 103 | 0.8
14 weeks | 3 months | 88 | 95 | 0.6 | INR 0.9
~1 year | | 57 | 76 | 0.7 | Albumin 4.5 g/dL
Normal Values | | <65 | <126 | <1.2

#### Comment

This case is a typical example of mild-to-moderate amoxicillin-clavulanate hepatotoxicity. The early appearance of itching and high alkaline phosphatase levels (~6 fold elevated) indicated that the injury was “cholestatic,” while the high AST and ALT levels (peak at 10-15 fold elevated) provided the evidence that the injury was “mixed”. The repeated courses of the combination within a short period of time may have predisposed to the hepatotoxicity. The jaundice and itching lasted only two weeks, and he eventually had full recovery.

### Case 3. Hepatocellular injury due to amoxicillin-clavulanate.(1)

A woman in her 20s received a ten-day course of amoxicillin-clavulanate (500 mg/125 mg) twice daily for suspected sinusitis. She felt somewhat nauseated during therapy, but was then without symptoms until 8 to 9 weeks after stopping therapy when she developed anorexia, nausea, vomiting and abdominal pain. She noted dark urine and jaundice and went to an emergency room where blood tests were taken showing a total bilirubin of 12.5 mg/dL, ALT 3500 U/L, AST 2554 U/L, and alkaline phosphatase 187 U/L. She was also on birth control pills and had intermittently taken cold and sinus remedies and loratadine for allergic sinusitis during the previous two months. She received a one-week course of nabumetone (a nonsteroidal antiinflammatory agent) and prednisone for acute neck spasms one month previously. She denied taking acetaminophen in the recent past and had no history of exposure to viral hepatitis or known risk factors for hepatitis or liver disease. She drank little alcohol and had never received amoxicillin-clavulanate previously. Tests for acute hepatitis A, B, C and E were negative as were tests for antinuclear and smooth muscle antibody. An ultrasound of the abdomen showed no evidence of biliary tract disease or gallstones. She did not undergo liver biopsy. Serum aminotransferase levels decreased while serum bilirubin rose to 27.2 mg/dL before falling (Table). Serum alkaline phosphatase levels were never very elevated. Prothrombin time was abnormal for a short period (peak INR 1.7). She recovered slowly and remained symptomatic with fatigue and abdominal discomfort for several months. When seen six months after onset of jaundice, she had no symptoms and serum bilirubin, aminotransferase and alkaline phosphatase levels had returned to normal.

#### Key Points

Medication: | Amoxicillin-clavulanate unknown dose twice daily for 14 days
Pattern: | Hepatocellular (R=66)
Severity: | 4+ (jaundice, hospitalization and INR >1.5)
Latency: | 80 days, 66 days since stopping medication
Recovery: | <2 months after onset of jaundice
Other medications: | Oral contraceptives for 4 years

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
14 days | 0 | Amoxicillin-clavulanate stopped
11 weeks | 66 days | Jaundice followed by fatigue and severe itching
12 weeks | 75 days | 3500 | 187 | 12.5 | Admission
13 weeks | 78 days | 955 | 156 | 16.4
14 weeks | 84 days | 438 | 159 | 16.3
| 89 days | 308 | 134 | 11.6
15 weeks | 91 days | 210 | 145 | 7.0 | Discharge
19 weeks | 4 months | 21 | 65 | 1.9 | Asymptomatic
Normal Values | | <42 | <115 | <1.2

#### Comment

This case is an example of moderate-to-severe amoxicillin-clavulanate hepatotoxicity. Somewhat atypical was the long incubation period between stopping the antibiotic and onset of jaundice as well as the prominent elevations in serum aminotransferase levels, the heights of which suggested viral hepatitis or acetaminophen overdose. The prominent ALT elevations and symptoms of fatigue and nausea rather than itching indicate a hepatocellular rather than cholestatic pattern of injury. The hepatocellular nature of the illness was also suggested by her symptoms which included abdominal pain and fatigue but not pruritus. Amoxicillin-clavulanate is typically associated with cholestatic injury but hepatocellular patterns can occur, particularly in younger patients such as this young woman. The potential role of other medications taken at the time (including unacknowledged receipt of acetaminophen) should be considered. While self-limited, the course of illness was severe and protracted. Further follow up is warranted to exclude a relapsing, acute onset of autoimmune hepatitis.

### Case 4. Mixed cholestatic-hepatocellular injury due to amoxicillin-clavulanate.(1)

A 60 year old man was hospitalized with cellulitis and was discharged on a 10-day course of amoxicillin-clavulanate (500 mg/125 mg) twice daily. At the time of hospitalization, he had normal serum bilirubin, alkaline phosphatase and aminotransferase levels. Five days after stopping the antibiotic, he developed itching followed by poor appetite. After ten days of symptoms, he noted dark urine and pale stools and was seen in an emergency room. He was given intravenous fluids for dehydration and hydroxyzine for itching. When laboratory tests showed a total bilirubin of 7.7 mg/dL, alkaline phosphatase 286 U/L, ALT 387 U/L, and AST 134 U/L, he was admitted for evaluation. Prothrombin time and albumin levels were normal. He had no previous history of liver disease and drank little alcohol. Over the previous week he had taken acetaminophen (up to 4 grams daily) for back pain and itching. On a chronic basis, he took montelukast (Singular) and used inhalers (with albuterol, fluticasone and salmeterol) for asthma; was prescribed losartan (Cozaar) for hypertension; and, used several topical lotions for psoriasis. Tests for acute hepatitis A, B and C were negative. He had IgG antibody to HEV but IgM anti-HEV was negative. Autoantibodies including antinuclear and smooth muscle antibodies were not detected. An abdominal ultrasound showed no evidence of biliary obstruction and no gallstones. A liver biopsy was obtained which showed a mixed hepatocellular-cholestatic pattern of injury compatible with drug induced liver disease. During the next several days serum bilirubin levels rose to 8.1 mg/dL, but then started to decline even as ALT and AST levels rose to 8 to 20 fold above normal and alkaline phosphatase to 2.5 times normal (Table). He was discharged after a week on symptomatic therapy with cholestyramine. He remained symptomatic with itching and fatigue for another month, but on a return visit two months after presentation he felt well and laboratory tests had returned almost to baseline values.

#### Key Points

Medication: | Amoxicillin-clavulanate 875/125 mg twice daily for 10 days
Pattern: | Mixed cholestatic-hepatocellular (R=3.9)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 24 days, 14 days after stopping
Recovery: | Within 2 months of stopping
Other medications: | Montelukast, fluticasone-salmeterol, albuterol, losartan, and synthroid chronically

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Baseline | | 44 | 65 | 0.6
10 days | 0 | Amoxicillin-clavulanate stopped
24 days | 14 days | 371 | 301 | 7.8 | Pain, itching
4 weeks | 19 days | 336 | 286 | 6.4 | Severe itching
5 weeks | 23 days | 695 | 244 | 3.7
5 weeks | 27 days | 724 | 188 | 2.3 | Biopsy
7 weeks | 5 weeks | 250 | 142 | 1.3
8 weeks | 6 weeks | 58 | 101 | 0.9
Normal Values | | <42 | <115 | <1.2

#### Comment

The history and presentation of this case were typical of moderately severe amoxicillin-clavulanate hepatotoxicity with onset of itching followed by jaundice occurring 1 to 2 weeks after stopping a ten-day course of treatment in an older man with no other obvious cause of liver disease. The pattern of serum enzyme results with prominent elevations in serum aminotransferase and alkaline phosphatase levels suggested mixed hepatocellular-cholestatic injury which was also shown by liver histology. While heavy acetaminophen use may have contributed to the initial aminotransferase elevations, the liver biopsy did not show evidence of typical acetaminophen injury. Other medications being taken (montelukast, albuterol, fluticasone, salmeterol, losartan) had been used chronically, have not or only rarely been linked to liver injury and were restarted without recurrence of liver disease. The drug induced liver injury was fully reversible, but symptoms and illness lasted for almost two months.

### Case 5. Cholestatic hepatitis due to clavulanate.(2)

A 20 year old woman developed jaundice 10 days after starting an intravenous regimen of amoxicillin-clavulanate (2 grams daily) for bacterial pneumonia and pleurisy. She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. Serum bilirubin, alkaline phosphatase, and aminotransferase levels were normal on admission, but rose gradually during the hospitalization and antibiotic therapy (Table). When jaundice was first noted laboratory testing showed a total bilirubin of 2.6 mg/dL (direct 1.9 mg/dL), ALT 112 U/L, AST 58 U/L, Alk P 425 U/L, and GGT 212 U/L. The amoxicillin-clavulanate was discontinued, but antibiotic therapy was still needed and she was treated with amoxicillin (3 grams daily) and metronidazole (1.5 grams daily). On this regimen, her pulmonary symptoms and fever improved rapidly and liver tests gradually improved and were in the normal range 30 days after stopping amoxicillin with clavulanate.

#### Key Points

Medication: | Amoxicillin-clavulanate intravenously for 10 days
Pattern: | Cholestatic (R=0.6)
Severity: | 3+ (jaundice, hospitalization prolonged)
Latency: | 10 days, still on therapy
Recovery: | Within 1 month of stopping
Other medications: | Amoxicillin, metronidazole

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | 0 | 39 | 112 | 0.5 | Admission
| | Intravenous amoxicillin-clavulanate started
1 day | 0 | 96 | 146 | 0.9
2 days | 0 | 75 | 206 | ..
5 days | 0 | 117 | 417 | ..
7 days | 0 | 112 | 425 | 2.6
10 days | 0 | Amoxicillin-clavulanate stopped
11 days | 1 day | 58 | 285 | 2.2
14 days | 4 day | 27 | 296 | 2.1 | Amoxicillin started
17 days | 7 day | 17 | 222 | 1.5
6 weeks | 4 weeks | 10 | 95 | 0.5
Normal Values | | <54 | <133 | <1.2

#### Comment

The history and presentation of this case were typical of mild amoxicillin-clavulanate hepatotoxicity with onset within a week of starting therapy. Of interest was that routine laboratory testing demonstrated a rapid onset of hepatic injury that was subclinical for the first week. The rapidity of onset suggests previous exposure to amoxicillin-clavulanate, although no such history was obtained. Once the antibiotic combination was stopped, recovery was prompt. Some form of antibiotic therapy was considered necessary and the attending physicians felt comfortable using amoxicillin as the injury was thought to be due to clavulanate rather than the penicillin. The subsequent course supported their conclusions. Several other cases in the literature have supported the belief that the injury in typical amoxicillin-clavulanate hepatotoxicity is due to clavulanate. However, in an individual case, there is always the possibility that the hepatic injury is actually due to the amoxicillin; although in that situation the clinical syndrome should be dominated by signs and symptoms of hypersensitivity (rash, fever, eosinophilia) usually arising within 1 to 2 weeks of starting therapy, features that can occur with typical amoxicillin-clavulanate liver injury but are generally mild and self-limited.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Amoxicillin-Clavulanate – Generic, Augmentin®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Amoxicillin%20and%20Clavulanate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Amoxicillin-Clavulanate | 79198-29-1 | C16-H19-N3-O5-S.C8-H9-N-O5
Amoxicillin Anhydrous | 26787-78-0 | C16-H19-N3-O5-S
Clavulanic Acid | 58001-44-8 | C8-H9-N-O5

## CITED REFERENCES

1 deLemos AS, Ghabril M, Rockey DC, Gu J, Barnhart HX, Fontana RJ, Kleiner DE, et al.; Drug-Induced Liver Injury Network (DILIN). Amoxicillin-clavulanate-induced liver injury. Dig Dis Sci 2016; 61: 2406-16.27003146
2 Peroux JL, Peroux E, Jais F, Philit F, Chichmanian RM. [Augmentin hepatotoxicity: responsibility of clavulanic acid? Apropos of a case] Gastroenterol Clin Biol 1992; 16: 102-3. French. 1537473

## ANNOTATED BIBLIOGRAPHY

References updated: 24 January 2026

Zimmerman HJ. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 589-638. (Expert review of hepatotoxicity published in 1999; amoxicillin-clavulanate is capable of causing acute liver injury with jaundice that is typically cholestatic in pattern but can be hepatocellular, onset is delayed as long as 35 days after the drug is stopped, etiology is idiosyncrasy likely to be immunologic, most likely due to the clavulanate, recovery in 30 to 74 days, rarely causes fatality).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics; amoxicillin-clavulanate typically causes a cholestatic or mixed pattern of injury with a preponderance in elderly men and with consecutive uses; features of hypersensitivity occur in up to 60% of patients; fatal, severe and prolonged cases have been described; mechanism is likely immunologic and due to the clavulanate rather than amoxicillin).
Petri WA Jr. Penicillins, cephalosporins, and other β-lactam antibiotics. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1477-1504. (Textbook of pharmacology and therapeutics).
Brogden RN, Carmine A, Heel RC, Morley PA, Speight TM, Avery GS. Amoxycillin/ clavulanic acid: a review of its antibacterial activity, pharmacokinetics and therapeutic use. Drugs 1981; 22: 337-62. (Review of structure, pharmacology, mechanism of action, therapeutic efficacy and safety of oral amoxicillin-clavulanate: "there have been occasional reports of mild increases in serum transaminase levels during treatment"). 7037354
van den Broek JW, Buennemeyer BL, Stricker BH. [Cholestatic hepatitis caused by a combination of amoxicillin and clavulanic acid (Augmentin)]. Ned Tijdschr Geneeskd 1988; 132: 1495-7. Dutch. (66 year old man developed fatigue and jaundice shortly after a 2nd course of amoxicillin-clavulanate [bilirubin 7.1 rising to 35 mg/dL, ALT 325 U/L, GGT 272 U/L], resolving in 3 months and recurring 4 days after restarting the combination but not with two courses of amoxicillin alone). 3173514
Verhamme M, Ramboer C, Van de Bruaene P, Inderadjaja N. Cholestatic hepatitis due to an amoxycillin/clavulanic acid preparation. J Hepatol 1989; 9: 260-4. (Two cases: 60 and 53 year old men developed jaundice and pruritus 3 weeks after starting 10 day course of amoxicillin-clavulanate [bilirubin 13.0 and 13.8 mg/dL, ALT 356 and 314 U/L, Alk P 647 and 273 U/L], resolving within 2 to 3 months). 2809168
Schneider JE, Kleinman MS, Kupiec JW. Cholestatic hepatitis after therapy with amoxicillin/clavulanate potassium. N Y State J Med 1989; 89: 355-6. (44 year old woman developed abdominal pain and jaundice 20 days after starting a 10 day course of amoxicillin-clavulanate [bilirubin 1.9 rising to 4.6 mg/dL, AST 129 U/L, Alk P 259 U/L], resolving within 2 months). 2739957
Dowsett JF, Gillow T, Heagerty A, Radcliffe M, Toadi R, Isle I, Russell RCG. Amoxycillin/clavulanic acid (Augmentin)-induced intrahepatic cholestasis. Dig Dis Sci 1989; 34: 1290-3. (75 year old man developed nausea followed by jaundice ~1 week after finishing a 10 day course of amoxicillin-clavulanate [bilirubin 4.7 rising to 16 mg/dL, ALT 225 U/L, Alk P 316 U/L, eosinophilia], biopsy showing cholestatic hepatitis, resolving in 14 weeks). 2752877
Reddy KR, Brillant P, Schiff ER. Amoxicillin-clavulanate potassium-associated cholestasis. Gastroenterology 1989; 96: 1135-41. (Between 1984-87, 18 cases of possible amoxicillin-clavulanate hepatotoxicity with adequate documentation were reported to the sponsor, including 7 cholestatic, 6 mixed and 4 hepatocellular cases; 16 with jaundice, 14 pruritus, 2 fever; eosinophilia in 60%; latency 2-43 days, 14 occurring after stopping; bilirubin 2.7-44 mg/dL, ALT 43-440 U/L, Alk P 63-1330 U/L, resolving in 30-74 days, no fatalities). 2925057
Stricker BH, Van den Broek JW, Keuning J, Eberhardt W, Houben HGJ, Johnson M, Blok APR. Cholestatic hepatitis due to antibacterial combination of amoxicillin and clavulanic acid (Augmentin). Dig Dis Sci. 1989; 34: 1576-80. (5 cases of suspected amoxicillin-clavulanate hepatotoxicity; all were men with jaundice arising 6-25 days after starting antibiotic [bilirubin 9-32 times ULN, ALT 2 to 6.3 times ULN, Alk P 1 to 2.6 times ULN], two were rechallenged and both had recurrence). 2791808
Cleau D, Jobard JM, Alves T, Gury S, Rey B, Vuillemard M, Noirot A, et al. [Cholestatic hepatitis induced by the amoxicillin-clavulanic acid combination. A case and review of the literature]. Gastroenterol Clin Biol 1990; 14: 1007-9. French. (50 year old man developed pruritus and jaundice a week after completing a 7 day course of amoxicillin-clavulanate [bilirubin 14.2 mg/dL, ALT 76 U/L, Alk P 526 U/L], resolving within 2 months). 2289658
Pelletier G, Ink O, Fabre M, Hagège H. [Hepatic cholestasis probably due to the combination of amoxicillin and clavulanic acid]. Gastroenterol Clin Biol 1990; 14: 601. French. (79 year old woman developed pruritus and jaundice 4 weeks after starting an 8 day course of amoxicillin-clavulanate [bilirubin 12.2 mg/dL, ALT 5 times ULN, Alk P 8.5 times ULN], resolving within 4 months). 2397873
Reddy KR, Schiff ER. Hepatitis and Augmentin. Dig Dis Sci 1990; 35: 1045-6. (Letter in response to Sticker commenting on the rarity of the injury in children despite wide scale use). 2384035
Michielsen PP, Van Outryve MJ, Van Marck EA, De Maeyer MH, Pelckmans PA, Van Maercke YM. Amoxycillin/clavulanic acid induced cholestasis. J Hepatol 1990; 11: 392. (24 year old man developed jaundice 23 days after starting 7 day course of amoxicillin-clavulanate [bilirubin 6.8 mg/dL, ALT 119 U/L, Alk P 275 U/L], resolving within 2 months). 2290034
Escallier F, Dalac S, Caillot D, Boulitrop C, Collet E, Lambert D. [Erythema multiforme, aplasia, cholestatic hepatitis during treatment with Augmentin (amoxicillin + clavulanic acid)]. Rev Med Interne 1990; 11: 73-5. French. (82 year old man developed rash 5 days after starting amoxicillin-clavulanate, which was continued for 3 more days when he developed fever, erythema multiforme, bone marrow aplasia, [platelets 13,000, leukocytes 200] and liver test abnormalities [ALT 88 U/L, Alk P 367 U/L], with complex course but ultimate recovery within next six months). 2326558
Alexander P, Roskams T, Van Steenbergen W, Peetermans W, Desmet V, Yap SH. Intrahepatic cholestasis induced by amoxicillin/clavulanic acid (Augmentin): a report on two cases. Acta Clin Belg 1991; 46: 327-32. (Two cases: 61 year old man developed pruritus and jaundice at end of 28 day course of amoxicillin-clavulanate [bilirubin 3.8 mg/dL, ALT 1.5 times ULN, Alk P 4 times ULN, eosinophils 9%], resolving within 12 weeks; 78 year old woman developed pruritus and jaundice 2 weeks after a course of amoxicillin-clavulanate [bilirubin 18.8 mg/dL, ALT 60 U/L, Alk P 682 U/L], resolving within 8 weeks). 1661553
Wong FS, Ryan J, Dabkowski P, Dudley FJ, Sewell RB, Smallwood RA. Augmentin-induced jaundice. Med J Aust 1991; 154: 698-701. (8 cases of amoxicillin-clavulanate associated jaundice, ages 45 to 77 years, 6 men, 2 women; onset 0.5 to 6 weeks after stopping [peak bilirubin 6.4 to 34.7 mg/dL, ALT 77 to 921 U/L, Alk P 188 to 1420 U/L], resolving in 2-21 weeks). 2034154
Silvain C, Fort E, Levillain P, Labat-Labourdette J, Beauchant M. Granulomatous hepatitis due to combination of amoxicillin and clavulanic acid. Dig Dis Sci 1992; 37: 150-2. (79 year old man developed jaundice 20 days after finishing 14 day course of amoxicillin-clavulanate [bilirubin 16.9 mg/dL, ALT 350 U/L, Alk P 1870 U/L, eosinophils 610], resolving within 11 weeks). 1728522
Ryan J, Dudley FJ. Cholestasis with ticarcillin-potassium clavulanate (Timentin). Med J Aust 1992; 156: 291. (75 year old man developed pruritus and jaundice 31 days after completing a 9 day course of intravenous ticarcillin/clavulanate and shortly after a 28 day course of induction chemotherapy for lymphoma [bilirubin 8.1 mg/dL, ALT 448 U/L, Alk P 1330 U/L], with persistent jaundice and death 4 weeks later while liver tests were improving). 1738336
Cabelleria Rovira E, Masso Ubeda RM, Arago López JV, Sanchís Closa A. [Cholestatic hepatitis from amoxicillin-clavulanic acid]. An Med Interna 1992; 9: 360-1. Spanish. (71 year old man developed pruritus and jaundice which resolved in 3 weeks and then recurred after a 3 day course of amoxicillin-clavulanate [bilirubin 17 mg/dL, ALT 126 U/L, Alk P 577 U/L], at which point a history of taking this antibiotic before the first episode was obtained). 1633249
Larrey D, Vial T, Micaleff A, Babany G, Morichau-Beauchant M, Michel H, Benhamou JP. Hepatitis associated with amoxycillin-clavulanic acid combination report of 15 cases. Gut 1992; 33: 368-71. (15 cases of amoxicillin-clavulanate hepatotoxicity reported to French regional centers including 12 men [80%], ages 39 to 82 years [mean=64], with latency of 7-60 days [mean=18], 11 arising after stopping, all had jaundice and 12 pruritus; no fatalities). 1568657
Hebbard GS, Smith KG, Gibson PR, Bhathal PS. Augmentin-induced jaundice with a fatal outcome. Med J Aust 1992; 156: 285-6. (81 year old man developed jaundice and pruritus 1 week after completing a 4 week course of amoxicillin-clavulanate [bilirubin 21.9 mg/dL, ALT 97 U/L, Alk P 231 U/L], with prolonged jaundice [bilirubin 35.8 mg/dL], drowsiness and death 5 weeks later). 1738330
Peroux JL, Peroux E, Jais F, Philit F, Chichmanian RM. [Augmentin hepatotoxicity: responsibility of clavulanic acid? Apropos of a case] Gastroenterol Clin Biol 1992; 16: 102-3. French. (20 year old woman developed jaundice 7 days after starting amoxicillin-clavulanate [bilirubin 3.7 mg/dL, ALT 112 U/L, Alk P 425 U/L], resolving within 30 days despite continuing treatment with amoxicillin). 1537473
Yap I, Gwee KA, Wee A. Augmentin-induced cholestatic jaundice--a case report. Singapore Med J 1993; 34: 464-5. (55 year old man with alcoholic pancreatitis developed jaundice after 6 days of amoxicillin-clavulanate [bilirubin 4.0 mg/dL, AST 56 U/L, Alk P 324 U/L], resolving within 5 weeks). 8153703
Horsmans Y; Geubel AP. Amoxycillin-clavulanic acid-erythromycin cross-liver toxicity: a case report. J Hepatol 1994; 21: 911-2. (67 year old man developed fatigue and pruritus 6 days after completing 5 day course of amoxicillin-clavulanate [bilirubin unclear, ALT 185 U/L, Alk P 235 U/L], and enzyme elevations later rose upon starting erythromycin [twice]). 7890912
Hanssens M, Mast A, Van Maele V, Pauwels W. [Cholestatic jaundice caused by amoxicillin-clavulanic acid in 4 patients]. Ned Tijdschr Geneeskd 1994; 138: 1481-3. Dutch. (4 cases of amoxicillin-clavulanate hepatotoxicity: 2 men and 2 women, ages 72 to 84 years, treated for 7-10 days with onset after 25-35 days with jaundice, fever and pruritus or abdominal pain [bilirubin 7.2-18.8 mg/dL, ALT 77-320 U/L, Alk P 195-630 U/L], resolving in 40-60 days). 8052321
Thomson JA, Fairley CK, Ugoni AM, Forbes AB, Purcell PM, Desmond PV, Smallwood RA, McNeil JJ. Risk factors for the development of amoxycillin-clavulanic acid associated jaundice. Med J Aust 1995; 162: 638-40. (Analysis of 34 cases of amoxicillin-clavulanate associated jaundice compared to 136 controls found male sex [65% vs 46%], older age [60 vs 40 years], longer treatment [5.7 vs 7 days], but not dose or other medical conditions, were more frequent in cases with liver injury). 7603374
Watteeuw G, Vasilevski D, Hautekeete M, Taton G, Lambilliotte JP, François E, Adler M. [Cholestatic hepatitis and amoxicillin-clavulanic acid combination. Personnel case report and literature review]. Rev Med Brux 1995; 16: 391-3. French. (58 year old man developed jaundice and pruritus 36 days after starting a 10 day course of amoxicillin-clavulanate, resolving within 2 months). 8570979
Galindo C, Buenestado J, Reñé JM, Piñol MC. [Acute pancreatitis associated with hepatotoxicity induced by amoxicillin-clavulanic acid] Rev Esp Enferm Dig 1995; 87: 597-600. Spanish. (25 year old man developed abdominal pain and jaundice 5 weeks after starting 6 day course of amoxicillin-clavulanate [bilirubin 7.0 mg/dL, ALT 268 U/L, Alk P 2287 U/L, amylase 878 U/L], resolving within 1 month). 7577112
Hautekeete ML. Hepatotoxicity of antibiotics. Acta Gastroenterol Belg 1995; 58: 290-6. (Review of hepatotoxicity of antibiotics including amoxicillin-clavulanate occurring after 1:10,000 to 1:100,000 prescriptions, particularly in older men who are treated repeatedly or with prolonged courses typically with cholestatic pattern of injury and with fever, rash and arthralgias in a minority of patients). 7491842
Hautekeete ML, Brenard R, Horsmans Y, Henrion J, Verbist L, Derue G, Druez P, et al. Liver injury related to amoxycillin-clavulanic acid: interlobular bile-duct lesions and extrahepatic manifestations. J Hepatol 1995; 22: 71-7. (Analysis of liver histology from 7 cases of amoxicillin-clavulanate hepatotoxicity; intralobular bile duct abnormalities found in all biopsies but no ductopenia). 7751590
Reddy KR, Schiff ER. Hepatotoxicity of antimicrobial, antifungal, and antiparasitic agents. Gastroenterol Clin North Am 1995; 24: 923-36. (Review of hepatotoxicity of antibiotics including amoxicillin-clavulanate; histologically centrizonal cholestasis is characteristic as well as mild-to-moderate inflammation and bile duct abnormalities). 8749905
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years’ experience. N Z Med J 1996; 109: 315-9. (Survey of adverse drug reaction reports found 943 causes of liver injury; amoxicillin-clavulanate was listed only for the last 7 year period [1988-94], during which it accounted for 32 cases [8%]). 8816722
García Rodríguez LA, Stricker BH, Zimmerman HJ. Risk of acute liver injury associated with the combination of amoxicillin and clavulanic acid. Arch Intern Med 1996; 156: 1327-32. (Analysis of General Practitioners Database of 93,433 users of amoxicillin-clavulanate [A/C] and 360,333 users of amoxicillin alone [A] identified 35 subsequent cases of idiopathic liver injury found 21 with A/C [1.7 per 10,000 prescriptions] compared to 17 with A [0.3 per 10,000], rate with A/C increasing with age, male sex and repeated use). 8651842
Pedro-Botet J, Supervía A, Barranco C, Solá R, Bruguera M. Intrahepatic cholestasis without hepatitis induced by amoxycillin/clavulanic acid. J Clin Gastroenterol 1996; 23: 137-8. (73 year old woman developed jaundice 5 days after starting amoxicillin-clavulanate [bilirubin 6.2 mg/dL, ALT 140 U/L, Alk P 1783 U/L], resolving within one month). 8877644
Bralet MP, Zafrani ES.[Hepatitis caused by the amoxicillin-clavulanic acid combination. An example of drug-induced biliary hepatotoxicity] Ann Pathol 1996; 16: 425-9. French. (Five cases of amoxicillin-clavulanate hepatotoxicity, biopsies showing centrolobular cholestasis in all and bile duct injury without ductopenia in 4). 9090930
Bustamante Balén M, Pérez Aguilar F, Rayón Martín M, García Herola A, Berenguer Lapuerta J. [Cholestatic hepatitis caused by amoxycillin-clavulanic acid. Report of a new case]. Gastroenterol Hepatol 1997; 20: 187-9. Spanish. (47 year old man developed pruritus and jaundice one month after starting amoxicillin-clavulanate [bilirubin 11.6 mg/dL, ALT 159 U/L, Alk P 195 U/L, 4% eosinophils], resolving within 3 months). 9280613
Reñe JM, Buenestado J, Piñol MC. [Hepatotoxicity caused by amoxicillin-clavulanic acid] Gastroenterol Hepatol 1997; 20: 337-8. Spanish. (Letter in response to Bustamante Balen discussing the link between amoxicillin and clavulanate and hypersensitivity liver injury). 9296855
Vial T, Biour M, Descotes J, Trepo C. Antibiotic-associated hepatitis: update from 1990. Ann Pharmacother 1997; 31: 204-20. (Systematic review of drug induced liver injury due to antibiotics from 1990 to 1995, several hundred cases of amoxicillin-clavulanate associated liver injury have been published occurring 1-4 weeks after stopping therapy with cholestatic or mixed enzyme elevations with jaundice and pruritus, typically in older men with longer courses of therapy; immunoallergic features are common and recurrence with shortened latency on rechallenge suggests immunologic basis, most likely due to clavulanate as some patients have tolerated amoxicillin by itself but had recurrence with combination; no apparent cross sensitivity with other beta lactamase inhibitors). 9034423
Caballero Plasencia AM, Valenzuela Barranco M, Martin Ruiz JL, Guilarte Lopez-Manas J. [Hepatotoxicity caused by amoxicillin, clavulanic acid or both?] Gastroenterol Hepatol 1997; 20: 45-6. Spanish. (31 year old man developed pruritis and jaundice the day after finishing a 5 day course of amoxicillin-clavulanate [bilirubin 2.9 mg/dL, ALT 291 U/L, Alk P 509 U/L], yet had tolerated amoxicillin alone and later had recurrence after 2 days of reexposure to amoxicillin-clavulanate [bilirubin 3.8 mg/dL, ALT 396 U/L, Alk P 616 U/L], resolving within 3 months of stopping). 9072200
de Haan F, Stricker BH. [Liver damage associated with the combination drug amoxicillin-clavulanic acid (Augmentin)]. Ned Tijdschr Geneeskd 1997; 141: 1298-301. Dutch. (Summary of 40 cases of amoxicillin-clavulanate hepatotoxicity reported to Dutch Drug Safety Unit between 1982-96, mean age 61 years, 70% men, latency mean=3 weeks from starting [maximum 55 days], resolved in all [mean=6 weeks, range 10 to 168 days], 5 had recurrence on reexposure). 9380177
Barrio J, Castiella A, Lobo C, Indart A, López P, García-Bengoechea M, Cosme A, et al. [Cholestatic acute hepatitis induced by amoxycillin-clavulanic acid combination. Role of ursodeoxycholic acid in drug-induced cholestasis] Rev Esp Enferm Dig 1998; 90: 523-6. Spanish. (Two cases: 68 year old man developed jaundice and pruritus 7 days after finishing 10 day course of amoxicillin-clavulanate [bilirubin 14.8 mg/dL, ALT 378 U/L, Alk P 542 U/L], resolving in 2 months; 95 year old man developed abdominal pain and jaundice 33 days after starting 2 week course [bilirubin 7.7 mg/dL, ALT 225 U/L, Alk P 1229 U/L], resolving within 2 months). 9741209
Nathani MG, Mutchnick MG, Tynes DJ, Ehrinpreis MN. An unusual case of amoxicillin/clavulanic acid-related hepatotoxicity. Am J Gastroenterol 1998; 93: 1363-5. (40 year old woman developed rash and jaundice 4 weeks after finishing 18 day course of amoxicillin-clavulanate [bilirubin 10.3 mg/dL, ALT 199 U/L, Alk P 362 U/L, eosinophils 7%], resolving and then recurring within 5 days of restarting [bilirubin 1.2 mg/dL, ALT 199 U/L, Alk P 362 U/L], resolving in 4 weeks). 9707067
Ballester Fayos J, Rodríguez Gil FJ, Paredes Arquiola JM, García del Castillo G, Antón-Conejero MD, Añón Rodríguez R, Moreno-Osset E. [Amoxicillin-clavulanic acid hepatotoxicity]. Gastroenterol Hepatol 1998; 21: 114-5. Spanish. 9580395
Julve R, García A, Gómez A, Primo J, Molés JR, Hinojosa J. [Acute hepatocellular lesion induced by amoxicillin-clavulanic acid]. Gastroenterol Hepatol 1998; 21: 92-4. Spanish. (21 year old man developed itching and jaundice 8 days after stopping a 10 day course of amoxicillin-clavulanate [bilirubin 11.8 rising to 33 mg/dL, ALT 840 U/L, Alk P 390 U/L], resolving within 10 weeks of onset). 9549187
Maggini M, Raschetti R, Agostinis L, Cattaruzzi C, Troncon MG, Simon G. Use of amoxicillin and amoxicillin-clavulanic acid and hospitalization for acute liver injury. Ann Ist Super Sanita 1999; 35: 429-33.10721209
Beurton I, Germanese JC, Becker MC, Koch S, Carbillet JP, Miguet JP, Bresson-Hadni S. [Acute hepatitis and destructive cholangitis probably induced by amoxicillin-clavulanic acid combination]. Gastroenterol Clin Biol 1999; 23: 1097-8. French. (73 year old developed jaundice 5 weeks after starting 2 week course of amoxicillin-clavulanate [bilirubin 20.1 mg/dL, ALT 12.5 times ULN, Alk P 3.5 times ULN], resolving within 6 weeks). 10592885
Soza A, Riquelme F, Alvarez M, Duarte I, Glasinovic JC, Arrese M. [Hepatotoxicity by amoxicillin/clavulanic acid: case report] Rev Med Chil 1999; 127: 1487-91. Spanish. (72 year old man developed jaundice and pruritus 36 days after starting 20 day course of amoxicillin-clavulanate [bilirubin 4.3 rising to 16 mg/dL, ALT 470 U/L, Alk P 400 U/L], resolving in 11 weeks with apparent clinical response to ursodiol therapy). 10835757
Hautekeete ML, Horsmans Y, Van Waeyenberge C, Demanet C, Henrion J, Verbist L, Brenard R, et al. HLA association of amoxicillin-clavulanate--induced hepatitis. Gastroenterology 1999; 117: 1181-6. (35 patients with amoxicillin-clavulanate hepatotoxicity were tested for HLA A and B class associations: DRB1*1501-DRB5*0101-DQB1*0602 haplotype found in 57% of cases vs 15% of controls; less common with hepatocellular injury pattern). 10535882
Limauro DL, Chan-Tompkins NH, Carter RW, Brodmerkel GJ Jr, Agrawal RM. Amoxicillin/clavulanate-associated hepatic failure with progression to Stevens-Johnson syndrome. Ann Pharmacother 1999; 33: 560-4. (37 year old man developed jaundice, rash and pruritus 3 weeks after stopping 10 day course of amoxicillin-clavulanate [bilirubin 27.7 mg/dL, ALT 53 U/L, Alk P 562 U/L, eosinophils 10%], with progression of rash to Stevens Johnson syndrome, septicemia and death). 10369618
Maggini M, Raschetti R, Agostinis L, Cattaruzzi C, Troncon MG, Simon G. Use of amoxicillin and amoxicillin-clavulanic acid and hospitalization for acute liver injury. Ann Ist Super Sanita. 1999; 35: 429-33. (Among 118 cases of acute liver injury seen at Italian regional hospitals, 2 were attributed to amoxicillin-clavulanate and 3 to amoxicillin alone). 10721209
O'Donohue J, Oien KA, Donaldson P, Underhill J, Clare M, MacSween RN, Mills PR. Co-amoxiclav jaundice: clinical and histological features and HLA class II association. Gut 2000; 47: 717-20. (22 cases of amoxicillin-clavulanate hepatotoxicity tested for HLA class II associations: DRB1*1501 found in 70% vs 20% of 134 controls: all had extended haplotype of DRB1*1501-DRB5*0101-DQA1*0102-DQB1*0602). 11034591
Bolzan H, Spatola J, Castelletto R, Curciarello J. [Intrahepatic cholestasis induced by amoxicillin alone]. Gastroenterol Hepatol 2000; 23: 237-9. Spanish. (24 year old woman developed pruritus at the end of a 10 day course of amoxicillin-clavulanate and jaundice 10 days later [bilirubin 10.5 mg/dL, ALT 30 U/L, Alk P 314 U/L], resolving within 2 months). 10902278
Chawla A, Kahn E, Yunis EJ, Daum F. Rapidly progressive cholestasis: An unusual reaction to amoxicillin/clavulanic acid therapy in a child. J Pediatr 2000; 136: 121-3. (2 year old boy developed rash 1 day after a 10 day course of amoxicillin-clavulanate with jaundice 3 days later [bilirubin 3.5 rising to 11 mg/dL, ALT 246 U/L, Alk P 630 U/L, GGT 555 U/L], with persistence of cholestasis requiring liver transplant 8 months later, explant showed vanishing bile duct syndrome). 10636987
Katsinelos P, Vasiliadis T, Xiarchos P, Patakiouta F, Christodoulou K, Pilpilidis I, Eugenidis N. Ursodeoxycholic acid (UDCA) for the treatment of amoxycillin-clavulanate potassium (Augmentin)-induced intra-hepatic cholestasis: report of two cases. Eur J Gastroenterol Hepatol 2000; 12: 365-8. (Two cases: 71 year old man developed jaundice 10 days after 7 day course of amoxicillin-clavulanate [bilirubin 6.4 mg/dL, ALT 77 U/L, Alk P 258 U/L], with slow resolution and apparent response to ursodiol; 81 year old man developed jaundice 1 week after a 1 week course [bilirubin 18.6 mg/dL, ALT 87 U/L, Alk P 427 U/L], resolving in 3 months and apparent response to ursodiol). 10750660
Gresser U. Amoxicillin-clavulanic acid therapy may be associated with severe side effects--review of the literature. Eur J Med Res 2001; 6: 139-49. (Systematic review of reports of adverse reactions to amoxicillin-clavulanate found 208 cases of liver injury, 158 could be evaluated: 70% men, mean age 60 years, mean duration of therapy 2 weeks, latency to onset averaging 25 days and mean time to resolution 12 weeks; 55% had mixed pattern of injury; 3 fatalities). 11309226
Berg P, Hahn EG. Hepatotoxic reactions induced by beta-lactamase inhibitors. Eur J Med Res 2001; 6: 535-42. (Systematic review of hepatotoxicity of beta lactamase inhibitors: convincing evidence for hepatotoxicity found only for combinations with clavulanate: case report of 55 year old man developing jaundice 2 weeks after a 14 day course of amoxicillin-clavulanate [bilirubin rising to ~22 mg/dL, Alk P ~800 U/L]). 11772541
Schey R, Avni Y, Bruck R, Shirin H. History of drug-induced hepatitis and risk of amoxicillin/clavulanate-induced hepatotoxicity. Ann Pharmacother 2001; 35: 1142-3. (Two cases: 62 year old man developed pruritus 2.5 weeks after finishing a 1 week course of amoxicillin-clavulanate [bilirubin 29.0 mg/dL, ALT 470 U/L, Alk P 271 U/L, eosinophils 8%], resolving within 5 weeks; 58 year old man developed pruritus 3 weeks after finishing 1 week course of therapy [bilirubin 5.5 mg/dL, ALT 248 U/L, Alk P 255 U/L, no eosinophilia], resolving within 6 weeks). 11573870
Boyd IW. Comment: history of drug-induced hepatitis and risk of amoxicillin/clavulanate-induced hepatotoxicity. Ann Pharmacother 2001; 35: 1677. (Letter in response to Schey [2001] mentioning that frequency of amoxicillin-clavulanate hepatotoxicity is estimated at 1.7 per 10,000 prescriptions and more than 300 cases have been reported from Australia). 11793648
Andrade RJ, Lucena MI, Fernández MC, Vega JL, Camargo R. Hepatotoxicity in patients with cirrhosis, an often unrecognized problem: lessons from a fatal case related to amoxicillin/clavulanic acid. Dig Dis Sci 2001; 46: 1416-9. (61 year old woman with cirrhosis developed jaundice 54 days after finishing a 21 day course of amoxicillin-clavulanate [bilirubin 27.1 mg/dL, ALT 73 U/L, Alk P normal], with progressive liver failure and death 11 days later). 11478492
Nicholson SC, Webb CD, Moellering RC Jr. Antimicrobial-associated acute hepatitis. Pharmacotherapy 2002; 22: 794-6; discussion 796-7. (Discussion of case described by Henann [2001] which was attributed to gatifloxacin, raising issues of possible role of hepatitis C, amoxicillin-clavulanate, clarithromycin and levofloxacin). 12066973
Jordán T, González M, Casado M, Suárez JF, Pulido F, Guerrero E, Esteban J. [Amoxicillin-clavulanic acid induced hepatotoxicity with progression to cirrhosis.] Gastroenterol Hepatol 2002; 25: 240-3. Spanish. (42 year old man developed pruritus and jaundice 5 weeks after starting 4 day course of amoxicillin-clavulanate, with prolonged course and worsening upon reexposure, liver biopsies showing progression to cirrhosis). 11975871
Sgro C, Clinard F, Ouazir K, Chanay H, Allard C, Guilleminet C, Lenoir C, et al. Incidence of drug-induced hepatic injuries: a French population-based study. Hepatology 2002; 36: 451-5. (All adverse drug reactions from French region from 1997-2000 found 34 cases of liver injury, 40 drugs involved, most common being amoxicillin-clavulanate [n=4]). 12143055
Ibáñez L, Pérez E, Vidal X, Laporte JR; Grup d'Estudi Multicènteric d'Hepatotoxicitat Aguda de Barcelona (GEMHAB). Prospective surveillance of acute serious liver disease unrelated to infectious, obstructive, or metabolic diseases: epidemiological and clinical features, and exposure to drugs. J Hepatol 2002; 37: 592-600. (Prospective study of acute serious liver disease over 6 years found 107 cases of drug induced liver injury, 13 [12%] attributed to clavulanate). 12399224
Thiim M, Friedman LS. Hepatotoxicity of antibiotics and antifungals. Clin Liver Dis 2003; 7: 381-99, vi-vii. (Review of antibiotic induced liver injury, including amoxicillin-clavulanate). 12879990
Zaidi SA. Hepatitis associated with amoxicillin/clavulanic acid and/or ciprofloxacin. Am J Med Sci 2003; 325: 31-3. (80 year old man developed rash 8 days after starting amoxicillin-clavulanate and 5 days after starting ciprofloxacin and found to have abnormal liver tests 5 days later [bilirubin 0.8 rising to 1.8 mg/dL, ALT 154 to 972 U/L, Alk P 120 to 358 U/L], resolving in 1 month). 12544082
Martí J. [Cholestatic hepatitis due to amoxicillin-clavulanic acid with positive re-exposure]. Enferm Infecc Microbiol Clin 2003; 21: 322-3. Spanish. (86 year old man developed jaundice after an 8 day course of amoxicillin-clavulanate [bilirubin 8.5 mg/dL, ALT 388 U/L, Alk P 337 U/L], resolving within 4 weeks; had a previous history of similar response). 12809593
Andrade RJ, Lucena MI, Alonso A, García-Cortes M, García-Ruiz E, Benitez R, Fernández MC, et al. HLA class II genotype influences the type of liver injury in drug-induced idiosyncratic liver disease. Hepatology 2004; 39: 1603-12. (Analysis of HLA Class II associations in 140 patients with drug induced liver injury: DRB1*1501 was increased in cholestatic cases compared to controls [35% vs 19%], among 27 cases due to amoxicillin-clavulanate, DRB1*1501 present in 33% suggesting association is with cholestatic liver injury rather than a specific drug). 15185301
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 137 were for non-acetaminophen drug induced acute liver failure, but only one [~1%] was attributed to amoxicillin-clavulanate). 15390328
de Abajo FJ, Montero D, Madurga M, García Rodríguez LA. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Br J Clin Pharmacol 2004; 58: 71-80. (Population based study of 1.6 million persons in UK and 128 valid cases of drug induced liver disease; amoxicillin-clavulanate was the most common cause [n=13] and had an incidence rate of 8.6 per 100,000 users). 15206996
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports to a Spanish network found 461 cases of drug induced liver disease, most common cause being amoxicillin-clavulanate [n=59: 13%]). 16083708
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Summary of 25 years of adverse drug reaction reporting in Sweden identified 103 cases of drug induced acute liver failure: none were attributed to amoxicillin-clavulanate). 16165719
Fontana RJ, Shakil AO, Greenson JK, Boyd I, Lee WM. Acute liver failure due to amoxicillin and amoxicillin/clavulanate. Dig Dis Sci 2005; 50: 1785-90. (Patient found to have abnormal liver tests [ALT 141 U/L, Alk P 98 U/L, normal bilirubin] 19 days after starting a 12 day course of amoxicillin-clavulanate, and admitted with acute liver failure 1 month later with bilirubin 27.6 mg/dL, ALT 620 U/L, Alk P 170 U/L, INR 2.0; dying 10 days later). 16187174
Andrade RJ, Lucena MI, Kaplowitz N, García-Munoz B, Borraz Y, Pachkoria K, García-Cortés M, et al. Outcome of acute idiosyncratic drug-induced liver injury: long-term follow-up in a hepatotoxicity registry. Hepatology 2006; 44: 1581-8. (At least 6 months follow up on 406 patients with drug induced liver injury in Spanish database identified 28 with evidence of chronic liver injury; amoxicillin-clavulanate accounted for 4 cases, rate of 6%; 3 had cholestatic enzyme pattern). 17133470
Lucena MI, Andrade RJ, Fernández MC, Pachkoria K, Pelaez G, Durán JA, Villar M, et al.; Spanish Group for the Study of Drug-Induced Liver Disease (Grupo de Estudio para las Hepatopatías Asociadas a Medicamentos (GEHAM)). Determinants of the clinical expression of amoxicillin-clavulanate hepatotoxicity: a prospective series from Spain. Hepatology 2006; 44: 850-6. (Series of 69 patients with amoxicillin-clavulanate hepatotoxicity which represented ~14% of drug induced liver injury; mean time to onset of jaundice 16 days [range 1-71], 2-55 days after stopping; 52% males; mean age 56 years; 31% cholestatic, 33% mixed and 36% hepatocellular; 1 patient died, 4 developed chronicity; hepatocellular cases were younger in age and had lower bilirubin and higher ALT levels). 17006920
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports; 21 drugs were associated with >50 cases, but not amoxicillin-clavulanate). 16054882
Cundiff J, Joe S. Amoxicillin-clavulanic acid-induced hepatitis. Am J Otolaryngol 2007; 28: 28-30. (Patient developed jaundice and pruritus 1 week after stopping a 4 week course of amoxicillin-clavulanate; laboratory results not given; resolution of jaundice in 3 weeks and enzyme elevations in 10 weeks). 17162128
Hussaini SH, O'Brien CS, Despott EJ, Dalton HR. Antibiotic therapy: a major cause of drug-induced jaundice in southwest England. Eur J Gastroenterol Hepatol 2007; 19: 15-20. (Analysis of 800 cases of jaundice presenting to a referral center in UK between 1998-2004, found 28 cases of drug induced liver injury; amoxicillin-clavulanate was the most common cause [n=9: 32%]). 17206072
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25:1401-9. (Population based survey of 126 cases of acute liver injury [24 with acute liver failure] due to drugs between 1993-1999 in Spain calculated relative risk of injury from amoxicillin-clavulanate to be 67 compared to the general population, and with an incidence rate of 27 per 100,000 person years of exposure). 17539979
Jakab SS, West AB, Meighan DM, Brown RS Jr, Hale WB. Mycophenolate mofetil for drug-induced vanishing bile duct syndrome. World J Gastroenterol 2007; 13: 6087-9. (69 year old man developed rash 3 weeks after starting amoxicillin-clavulanate with subsequent jaundice [bilirubin 1.0 rising to 7.4 mg/dL, ALT 82 GGT 360 U/L], with prolonged jaundice and vanishing bile duct syndrome but subsequent resolution with mycophenolate mofetil therapy). 18023105
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, amoxicillin-clavulanate was the most common single cause accounting for 23 cases [8%]). 18955056
Domínguez Jiménez JL, Marín Moreno M, Bernal Blanco E, Puente Gutiérrez JJ, Guiote Malpartida S, de la Mata García M. [Acute cholestatic hepatitis induced by amoxicillin-clavulanic acid]. Gastroenterol Hepatol 2008; 31: 46. Spanish. (36 year old former alcoholic developed jaundice 10 days after stopping fluconazole and 10 days after stopping 3 day course of amoxicillin-clavulanate [bilirubin 18.7 mg/dL, ALT 128 U/L, AST 125 U/L, Alk P 539 U/L, 26% eosinophils], with subsequent worsening jaundice and ascites but eventual recovery in 2 months: acute on chronic injury). 18218281
Daly AK, Day CP. Genetic association studies in drug-induced liver injury. Semin Liver Dis 2009; 29: 400-11. (Review of genetic associations reported with drug induced liver injury; linkage of DRB1*1501 and amoxicillin-clavulanate liver toxicity found in two of three studies). 19826974
Hunt CM. Mitochondrial and immunoallergic injury increase risk of positive drug rechallenge after drug-induced liver injury: a systematic review. Hepatology 2010; 52: 2216-22. (Review of safety of rechallenge after clinically apparent drug induced liver injury including discussion of amoxicillin-clavulanate). 21105110
Donaldson PT, Daly AK, Henderson J, Graham J, Pirmohamed M, Bernal W, Day CP, Aithal GP. Human leucocyte antigen class II genotype in susceptibility and resistance to co-amoxiclav-induced liver injury. J Hepatol 2010; 53: 1049-53. (HLA testing in 61 patients with amoxicillin-clavulanate liver injury found increase in HLA-DRB1*15 [53% vs 30%] and reduction in DRB1*07 [10% vs 29%], but no correlations with clinical features). 20800921
Invernizzi P. Drug-induced liver injury: is it time for genetics to change our clinical practice? J Hepatol 2010; 53: 993-4. (Editorial accompanying article by Donaldson [2010]). 20851491
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India: amoxicillin-clavulanate accounted for only 3 cases [1%]). 20648003
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, amoxicillin-clavulanate accounting for 38 cases [0.4%] for an adjusted odds ratio of 1.7). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury none of which were attributed to the combination of amoxicillin and clavulanate, although two were attributed to amoxicillin alone). 20949552
Herrero-Herrero JI, García-Aparicio J. Corticosteroid therapy in a case of severe cholestasic hepatitis associated with amoxicillin-clavulanate. J Med Toxicol 2010; 6: 420-3. (76 year old man developed fever, pruritus and jaundice 4 weeks after starting a 3 week course of amoxicillin-clavulanate [bilirubin 2.2 rising to 50.1 mg/dL, ALT 352 U/L, Alk P 266 U/L, eosinophils 8%], with prompt clinical response to prednisone [1 mg/kg/day] and ursodiol and recovery in 10 weeks). 20237968
Lucena MI, Molokhia M, Shen Y, Urban TJ, Aithal GP, Andrade RJ, Day CP, et al; Spanish DILI Registry; EUDRAGENE; DILIN; DILIGEN; International SAEC. Susceptibility to amoxicillin-clavulanate-induced liver injury is influenced by multiple HLA class I and II alleles. Gastroenterology 2011; 141: 338-47. (Genome wide association study of 201 patients with amoxicillin-clavulanate liver injury from Europe and the US [Caucasians only] found an association with the class II extended allele HLA-DRB1*15:01-DQB1*06:02, which had been previously shown, as well as a separate but interacting linkage to a class 1 region: HLA-A*02:01). 21570397
Urban TJ, Shen Y, Stolz A, Chalasani N, Fontana RJ, Rochon J, Ge D, et al.; Drug-Induced Liver Injury Network; DILIGEN; EUDRAGENE; Spanish DILI Registry; International Serious Adverse Events Consortium. Limited contribution of common genetic variants to risk for liver injury due to a variety of drugs. Pharmacogenet Genomics 2012; 22: 784-95. (Genome wide association study done on 783 patients with suspected drug induced liver injury found an association of hepatocellular injury with a single nucleotide polymorphism in the vicinity of STAT4). 22968431
Hita EO, García JA, Gonzalez JC, Molina AA, Cordero MA, Escobar JS, Ruiz-Extremera A. Amoxicillin-clavulanic acid hepatotoxicity in children. J Pediatr Gastroenterol Nutr 2012; 55: 663-7. (Among 24 cases of drug induced liver injury enrolled in a prospective database from 8 pediatric centers in Spain [2008-2011], 11 were due to amoxicillin-clavulanate; ages 1 to 11 years, 11 boys and 2 girls, 3 to 29 days after starting [4 were still taking drug when symptoms arose], 64% of cases were hepatocellular and bilirubin was normal in all except one, children presented with nausea, vomiting and abdominal pain rather than itching and jaundice). 22710999
Studniarz M, Czubkowski P, Cielecka-Kuszyk J, Jankowska I, Teisseyre M, Kamińska D, Markiewicz M, et al. Amoxicillin/clavulanic acid-induced cholestatic liver injury after pediatric liver transplantation. Ann Transplant 2012; 17: 128-31. (8 year old boy with biliary atresia and liver transplant on corticosteroids and tacrolimus developed jaundice 2 days after finishing a 2 week course of amoxicillin-clavulanate [bilirubin 5.3 mg/dL, ALT 227 U/L, Alk P not provided], resolving within 12 weeks). 22466919
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, Park JW, Hong CS. Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci 2012; 27: 268-73. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, only one of which was attributed to amoxicillin-clavulanate). 22379337
Sánchez-Ruiz-Granados E, Bejarano-García A, Uceda-Torres E. Recurrent cholestasis by amoxicillin-clavulanic acid: the importance of a correct diagnosis of hepatotoxicity. Rev Esp Enferm Dig 2012; 104: 616-7. (62 year old man with a hepatic hydatid cyst and previous episode of unexplained jaundice, redeveloped jaundice and pruritus 20 days after starting amoxicillin-clavulanate [bilirubin 12 mg/dL, ALT and Alk P normal]). 23368660
Stephens C, López-Nevot MÁ, Ruiz-Cabello F, Ulzurrun E, Soriano G, Romero-Gómez M, Moreno-Casares A, et al. HLA Alleles Influence the Clinical Signature of Amoxicillin-Clavulanate Hepatotoxicity. PLoS One 2013; 8: e68111. (Analysis of HLA alleles in 75 cases of amoxicillin-clavulanate hepatotoxicity found several associations of specific alleles with clinical features). 23874514
Girelli F, Bernardi S, Gardelli L, Bassi B, Parente G, Dubini A, Serra L, Nizzoli M. A new case of DRESS syndrome induced by sulfasalazine and triggered by amoxicillin. Case Rep Rheumatol 2013; 2013: 409152. (53 year old woman with uveitis developed sore throat, fever and lymphadenopathy 6 weeks after starting sulfasalazine which was treated with amoxicillin-clavulanate whereupon she developed worsening fever, rash and was found to have liver injury [bilirubin 2.7 mg/dL, ALT 350 U/L, Alk P 2959 U/L, INR normal], responding to methylprednisolone and stopping drugs; role of amoxicillin-clavulanate being uncertain in this onset of DRESS syndrome with sulfasalazine therapy). 23936716
Ferrajolo C, Verhamme KM, Trifirò G, 't Jong GW, Giaquinto C, Picelli G, Oteri A, et al. Idiopathic acute liver injury in paediatric outpatients: incidence and signal detection in two European countries. Drug Saf 2013; 36: 1007-16. (Analysis of 3 large pediatric healthcare databases form Italy and the Netherlands [2000-2008] identified 785 cases of idiopathic acute liver injury in children: 73/100,000 in Italy and 21/100,000 in Holland, linked to 110 possible medications, adjusted relative risks was greatest for clarithromycin [26], amoxicillin-clavulanate [19], amoxicillin [7.5] and for combinations of isoniazid and rifampin [4852] and acetaminophen [94]). 23591830
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 due to amoxicillin-clavulanate making it the most common cause, estimated to occur after 1 per 2350 prescriptions; 13 cases were symptomatic, but only 6 were jaundiced and none were fatal). 23419359
Sistanizad M, Peterson GM. Drug-induced liver injury in the Australian setting. J Clin Pharm Ther 2013; 38: 115-20. (Among 17 cases of suspected drug induced liver injury seen at a single referral hospital in Tasmania over a 12 month period, 11 were due to antibiotics including flucloxacillin in 4, amoxicillin in 2, amoxicillin-clavulanate in 2, and rifampin, moxifloxacin and ciprofloxacin in 1 each). 23350857
Beraldo DO, Melo JF, Bonfim AV, Teixeira AA, Teixeira RA, Duarte AL. Acute cholestatic hepatitis caused by amoxicillin/clavulanate. World J Gastroenterol 2013; 19: 8789-92. (63 year old man developed jaundice and pruritus arising 45 days after a course of amoxicillin-clavulanate [bilirubin 8.3 mg/dL, ALT 200 U/L, Alk P 60 U/L], with severe course but ultimate recovery). 24379601
Devarbhavi H, Andrade RJ. Drug-induced liver injury due to antimicrobials, central nervous system agents, and nonsteroidal anti-inflammatory drugs. Semin Liver Dis. 2014; 34: 145-61. (Review of drug induced liver injury from various classes of agents, mentions that amoxicillin-clavulanate is the leading cause of drug induced liver injury, marked by a latency of several days to weeks, often after stopping the antibiotic, the injury varying from cholestatic to hepatocellular and the mortality rate being as high as 7%). 24879980
Björnsson ES. Epidemiology and risk factors for idiosyncratic drug-induced liver injury. Semin Liver Dis 2014; 34: 115-22. (Estimates of the incidence of drug induced liver injury have ranged from 2 to 19 cases per 100,000 inhabitants, probably because of variation in medication use, definitions used and rigor of capturing all patients in a population; in recent studies, amoxicillin-clavulanate has been the most frequently implicated drug). 24879977
Kaye JA, Castellsague J, Bui CL, Calingaert B, McQuay LJ, Riera-Guardia N, Saltus CW, et al. Risk of acute liver injury associated with the use of moxifloxacin and other oral antimicrobials: a retrospective, population-based cohort study. Pharmacotherapy 2014; 34: 336-49. (In a US healthcare database with 1.3 million antimicrobial users there were 607 cases of liver injury and 11 cases of liver failure, the highest relative risk for current single use being 3.2 for levofloxacin, 2.5 for amoxicillin-clavulanate, 2.5 for doxycycline, 2.3 for moxifloxacin and 2.3 for amoxicillin). 24865821
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 3 of which were caused by amoxicillin-clavulanate). 24552865
Fontana RJ. Pathogenesis of idiosyncratic drug-induced liver injury and clinical perspectives. Gastroenterology 2014; 146: 914-28. (Review of clinical phenotypes and pathogenesis of different forms of drug induced liver injury including antibiotics and amoxicillin-clavulanate). 24389305
Leise MD, Poterucha JJ, Talwalkar JA. Drug-induced liver injury. Mayo Clin Proc 2014; 89: 95-106. (Review of drug induced liver injury mentions that antibiotics are the most common cause and amoxicillin-clavulanate the most common single cause in Europe and the US, accounting for 8-22% of cases). 24388027
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 91 [12%] were attributed to amoxicillin-clavulanate, making it rank first among 177 implicated agents and well ahead of the second ranked drug isoniazid with 49 cases [6.5%]). 25754159
Yazici C, Mutlu E, Bonkovsky HL, Russo MW. Risk factors for severe or fatal drug-induced liver injury from amoxicillin-clavulanic acid. Hepatol Res 2015; 45: 676-82. (Systematic review of amoxicillin-clavulanate associated liver injury literature found exposure to hepatotoxic co-medications was most common in fatal cases [21%: 3 of 14) than in cases with subsequent recovery [2.3%: 2 of 89]). 25163514
Pavlos R, Mallal S, Ostrov D, Buus S, Metushi I, Peters B, Phillips E. T cell-mediated hypersensitivity reactions to drugs. Annu Rev Med 2015; 66: 439-54. (Review of HLA associations of drug hypersensitivity reactions and 3 hypothetical models to explain T cell responses to drugs: mediated by haptens, pharmacological interactions or altered peptide repertoires). 25386935
Guéant JL, Romano A, Cornejo-Garcia JA, Oussalah A, Chery C, Blanca-López N, Guéant-Rodriguez RM, et al. HLA-DRA variants predict penicillin allergy in genome-wide fine-mapping genotyping. J Allergy Clin Immunol 2015; 135: 253-9. (In a genome wide association study of 387 patients with immediate allergic reactions to beta-lactam antibiotics, several class 2 HLA associations [HLA-DRA regions] were found for penicillin responses, but they did not apply to cephalosporin cases). 25224099
Björnsson ES. Drug-induced liver injury: an overview over the most critical compounds. Arch Toxicol 2015; 89: 327-34. (Review of the most common causes of drug induced liver injury in 3 recent surveys all of which listed amoxicillin-clavulanate as the most frequent cause). 25618544
Mengual-Moreno E, Lizarzábal-García M, Ruiz-Soler M, Silva-Suarez N, Andrade-Bellido R, Lucena-González M, Bessone F, et al. [Case reports of drug-induced liver injury in a reference hospital of Zulia state, Venezuela]. Invest Clin 2015; 56: 3-12. Spanish. (Among 13 patients with drug induced liver injury presenting at a single referral hospital in Venezuela over a 1 year period, the most common causes were ibuprofen (n=3), acetaminophen ([n=3], isoniazid [n=2] and Herbalife products [n=2]; 1 self-limited but slow to recover case was attributed to amoxicillin-clavulanate in a 64 year old man [bilirubin 36.1 mg/dL, ALT 66 U/L, Alk P 629 U/L]). 25920181
Yaseen FS, Saide K, Kim SH, Monshi M, Tailor A, Wood S, Meng X, et al. Promiscuous T-cell responses to drugs and drug-haptens. J Allergy Clin Immunol 2015; 136: 474-6.e8. (T cell responses to either soluble or dendritic cell processed amoxicillin or clavulanate were detected in selected patients with a history of amoxicillin-clavulanate induced liver injury and were HLA restricted). 25910715
Suzuki A, Yuen NA, Ilic K, Miller RT, Reese MJ, Brown HR, Ambroso JI, et al. Comedications alter drug-induced liver injury reporting frequency: Data mining in the WHO VigiBase™. Regul Toxicol Pharmacol 2015 72: 481-90. (Analysis of the WHO VigiBase for possible effects of co-medications in drug induced liver injury using acetaminophen, isoniazid, valproate and amoxicillin-clavulanate found evidence of a decrease or an increase in case incidence for different co-medications). 25988394
Kim SH, Saide K, Farrell J, Faulkner L, Tailor A, Ogese M, Daly AK, et al. Characterization of amoxicillin- and clavulanic acid-specific T cells in patients with amoxicillin-clavulanate-induced liver injury. Hepatology 2015; 62: 887-99. (Lymphocytes from 6 of 7 patients with a history of amoxicillin-clavulanate induced liver injury showed significant proliferation or cytokine release in response to amoxicillin or clavulanate in vitro, and T cell clones responding to each drug were produced that were HLA-resisted, but not cross reactive). 25998949
Moreno L, Sánchez Delgado J, Vergara M, Casas M, Miquel M, Dalmau B. Recurrent drug-induced liver injury (DILI) with ciprofloxacin and amoxicillin/clavulanic. Rev Esp Enferm Dig. 2015 Dec; 107: 767-8. (Case report of a patient who developed drug induced liver injury attributed to ciprofloxacin and subsequently a separate episode due to amoxicillin-clavulanate). 26671593
Ferrer P, Amelio J, Ballarín E, Sabaté M, Vidal X, Rottenkolber M, Schmiedl S, et al.; PROTECT Work Package 2. Systematic review and meta-analysis: macrolides and amoxicillin/clavulanate-induced acute liver injury. Basic Clin Pharmacol Toxicol 2016; 119: 3-9. (Metaanalysis of placebo controlled trials of macrolides and amoxicillin-clavulanate found significant increased risk of ALT elevations with erythromycin but not clarithromycin, telithromycin or amoxicillin-clavulanate; no mention of azithromycin). 26707367
Björnsson ES. Hepatotoxicity by drugs: the most common implicated agents. Int J Mol Sci 2016; 17: 224. (Review of the most common causes of drug induced liver injury based upon categorization from LiverTox). 26861310
deLemos AS, Ghabril M, Rockey DC, Gu J, Barnhart HX, Fontana RJ, Kleiner DE, et al.; Drug-Induced Liver Injury Network (DILIN). Amoxicillin-clavulanate-induced liver injury. Dig Dis Sci 2016; 61: 2406-16. (Among 1038 cases of drug induced liver injury enrolled in a US database between 2004 and 2014, 117 were attributed to amoxicillin-clavulanate [9%]; mean age 60 years, 62% men, mean latency 29 days, mostly jaundiced and cholestatic [median bilirubin 6 mg/dL, ALT 362 U/L, Alk P 288 U/L, R value 2.7], 3 underwent liver transplant with resolution in almost all cases, although sometimes delayed). 27003146
Meng X, Earnshaw CJ, Tailor A, Jenkins RE, Waddington JC, Whitaker P, French NS, et al. Amoxicillin and clavulanate form chemically and immunologically distinct multiple haptenic structures in patients. Chem Res Toxicol 2016; 29: 1762-72. (Analysis of amoxicillin and clavulanate adducts produced in vitro and detected in vivo in patients with amoxicillin-clavulanate hepatotoxicity, the adducts were also present in culture median used to detect reactivity of specific T cell clones from patients ). 27603302
Lee J, Ji SC, Kim B, Yi S, Shin KH, Cho JY, Lim KS, Lee SH, Yoon SH, et al. Exploration of biomarkers for amoxicillin/clavulanate-induced liver injury: multi-omics approaches. Clin Transl Sci 2017; 10: 163-71. (Among 30 Korean, male healthy volunteers treated with amoxicillin-clavulanate twice daily for 14 days, serum ALT levels doubled in 6 becoming abnormal in only one, these changes accompanied by increases in miRNA122 and with a positive lymphocyte stimulation response to clavulanate in one subject but not with higher plasma levels of either agent). 27785887
Munz M, Grummich H, Birkmann J, Wilhelm M, Holzgrabe U, Sörgel F. Severe drug-Induced liver injury as an adverse drug event of antibiotics: a case report and review of the literature. Chemotherapy 2017; 62: 367-73. (20 year old woman received 4 antibiotics [amoxicillin, ciprofloxacin, cefazolin and clindamycin] and acetaminophen within weeks of developing rash, fever and jaundice [bilirubin 3.7 mg/dL, ALT 1219 U/L, Alk P 143 U/L, GGT 201 U/L, INR 1.6], with worsening and signs of hepatic failure but subsequent spontaneous and complete resolution, the specific cause being obscure because of the many drug exposures). 28934748
Visentin M, Lenggenhager D, Gai Z, Kullak-Ublick GA. Drug-induced bile duct injury. Biochim Biophys Acta Mol Basis Dis 2018; 1864(4 Pt B): 1498-506. (Review of drug induced bile duct injury focusing on agents flucloxacillin and amoxicillin-clavulanate that injure small ducts and fluorouracil [given by hepatic artery], ketamine, scolicidal agents [for Hydatid disease given into the cysts] that injure larger ducts causing a sclerosing cholangitis like picture). 28882625
Takeuchi Y, Shinozaki T, Kumamaru H, Hiramatsu T, Matsuyama Y. Analyzing intent-to-treat and per-protocol effects on safety outcomes using a medical information database: an application to the risk assessment of antibiotic-induced liver injury. Expert Opin Drug Saf 2018; 17: 1071-9. (Cohort matching of cases with vs without antibiotic therapy in a large electronic medical record database from the University of Tokyo Hospital from 2011 to 2015 with adjustments found rates of liver test abnormalities within 30 days of starting penicillins [25.2 per 1000] was higher than that of fluoroquinolones [11.4] and macrolide antibiotics [8.1] as well as controls [6.5 to 7.1]). 30252549
Vilà-Nadal G, Lleonart Bellfill R, Martí Garrido J, Baliellas Comellas C, Corominas Sánchez M. Recurrent drug-induced liver injury with cetirizine and amoxicillin-clavulanate potassium. J Investig Allergol Clin Immunol 2019; 29: 321-2. (35 year old woman developed fatigue and jaundice shortly after finishing a 12 day course of antibiotics consisting of 8 days of amoxicillin and 4 of amoxicillin-clavulanate [bilirubin 6.3 mg/dL, ALT 2139 U/L, and Alk P132 U/L], having had a similar episode 13 years earlier that arose 1 month after starting cetirizine [bilirubin 8.8 mg/dL, ALT 1873 U/L, Alk P 120], recovering rapidly and completely from both episodes). 30957759
Cirulli ET, Nicoletti P, Abramson K, Andrade RJ, Björnsson ES, Chalasani N, Fontana RJ, et al.; Drug-Induced Liver Injury Network (DILIN) investigators; International DILI consortium (iDILIC). A missense variant in PTPN22 is a risk factor for drug-induced liver injury. Gastroenterology 2019; 156: 1707-16.e2. (Genome wide association studies on 2048 patients with drug induced liver injury and 12,439 controls identified a variant in PTPN22 which was highly associated with liver injury, allele frequency being 0.12 among cases and 0.08 among controls with highest association in Northern Europeans and in cases of amoxicillin clavulanate, PTPN22 being a cellular kinase involved in modulation of immune reactions). 30664875
Li L, Zheng S, Chen Y. Stevens-Johnson syndrome and acute vanishing bile duct syndrome after the use of amoxicillin and naproxen in a child. J Int Med Res 2019; 47: 4537-43. (6 year old boy developed rash and jaundice shortly after receiving amoxicillin and naproxen [bilirubin 3.1 mg/dL, ALT 942 U/L, Alk P 318 U/L, GGT 150 U/L, INR 1.1], with progression of rash to Stevens Johnson syndrome requiring high dose corticosteroid therapy and worsening of liver disease [peak bilirubin 20.4 mg/dL, peak GGT 981 U/L], which persisted for 4 months but eventually resolved although Alk P and GGT remained slightly abnormal at 6 months). 31448655
Alshabeeb MA, Aithal GP, Daly AK. Investigation of oxidative stress-related candidate genes as risk factors for drug-induced liver Injury due to co-amoxiclav. DNA Cell Biol 2020; 39: 349-54. (Among 165 patients with amoxicillin-clavulanate liver injury there was no increase frequency of variants in SOD2, GPX1, GSTM1 and GSTT1, which had previously been implicated in playing a role in pathogenesis). 31905014
Aggarwal A, Jaswal N, Jain R, Elsiesy H. Amoxicillin-clavulanate-induced granulomatous hepatitis: case report and review of the literature. J Clin Transl Hepatol. 2019;7:280-283. (58 year old woman developed abdominal pain and dark urine following a 7-day course of amoxicillin-clavulanate [bilirubin 3.2 mg/dL, ALT 388 U/L, Alk P 510 U/L, eosinophilia 8%], a liver biopsy showing portal granulomas, mononuclear cells and eosinophils; recovery was slow and delayed but follow up biopsy showed disappearance of granulomas). 31608221
Alhaddad O, Elsabaawy M, Abdelsameea E, Abdallah A, Shabaan A, Ehsan N, Elrefaey A, et al. Presentations, causes and outcomes of drug-induced liver injury in Egypt. Sci Rep. 2020;10:5124. (Among 75 patients with drug-induced liver injury seen at an Egyptian referral center between 2015 and 2016, 56 [71%] were in patients with chronic hepatitis C, and the most common causes were diclofenac [41%], amoxicillin-clavulanate [19%], halothane [11%], ibuprofen [5%], and khat [4%]). 32198411
Schosheim A, Mockler D, Chawla A. Does genetics play a role in acute liver injury after amoxicillin exposure? ACG Case Rep J. 2020;7: (Two sisters, developed jaundice shortly after receiving oral amoxicillin-clavulanate [3 year old] and amoxicillin [1 year old] with bilirubin of 6.4 and 6.7 mg/dL, ALT 4343 and 2667 U/L, GGT 151 U/L and Alk P 578 U/L, suggesting that genetic factors contribute to shared risk of liver injury after amoxicillin and amoxicillin-clavulanate). 33062772
Worland T, Chin KL, Rodrigues B, Nicoll A. A retrospective case-controlled cohort study of inpatient drug induced liver injury: the RIDDLE study. Transl Gastroenterol Hepatol. 2020;5:33. (Among 119 cases of suspected drug-induced liver injury identified between 2011 and 2017 from electronic medical records from a large Australian health service, the most common causes were amoxicillin-clavulanate [14%] and flucloxacillin [8%]). 32632384
Ahmed S, Onteddu NK, Jabur A, Vulasala SSR, Kolli S. Delayed presentation of drug-induced hepatic injury. Cureus. 2020;12(8):e9713. (A 20 year old woman developed jaundice 4 months after a 10-day course of amoxicillin-clavulanate with prolonged jaundice [bilirubin 6.9 mg/dL, ALT 57 U/L, Alk P 207 U/L] responding to therapy with corticosteroids and ursodiol, but with no information on long-term follow up off of therapy). 32944435
Ferreira I, Gouveia C, Vasques C Sr, Faria C, Pedroso A. Drug-induced liver injury caused by amoxicillin/clavulanate. Cureus. 2020;12:e12234. (71 year old man developed jaundice a few days after finishing a 14-day course of amoxicillin-clavulanate [bilirubin 8.8 mg/dL, ALT 193 U/L, Alk P 262 U/L] requiring 4 to 5 months for full recovery). 33500857
Weersink RA, Alvarez-Alvarez I, Medina-Cáliz I, Sanabria-Cabrera J, Robles-Díaz M, Ortega-Alonso A, García-Cortés M, et al. Clinical characteristics and outcome of drug-induced liver injury in the older patients: from the young-old to the oldest-old. Clin Pharmacol Ther. 2021;109:1147-1158. (Among 882 patients with drug induced liver injury enrolled in a prospective Spanish Registry between 1994 and 2018, patients above the age of 65 years had higher initial levels of serum bilirubin and Alk P, and were more likely to have cholestatic liver injury [27% vs 14%] and have amoxicillin-clavulanate as the suspected cause [19% vs 29%] vs younger patients, while severity and liver-related death rates were similar ). 33179256
Lee MQ, Chigozie R, Khan I, O'Mara G. Prednisolone: role in amoxicillin-clavulanate-induced cholestatic liver injury. BMJ Case Rep. 2021;14:e239488. (68 year old woman with alcoholic liver disease developed worsening liver tests 11 days after finishing a 5 day course of amoxicillin-clavulanate which peaked 1-2 weeks later [bilirubin initially 0.3 rising to 0.7 and peaking at 3.8 mg/dL, ALT initially 54 and peaking at 351 U/L, Alk P 282 and peaking at 986 U/L] improving with prednisone therapy, biopsy not done). 33795270
Park JH, Hong S, Jun DW, Yoon JH, Lee KN, Lee HL, Lee OY, Yoon BC, Choi HS. Prevalence and clinical characteristics of antibiotics associated drug induced liver injury. Ann Transl Med. 2021;9:642. (Among patients with suspected drug induced liver injury hospitalized during a 1-year period (2017-18] at a single Korean referral center, antibiotics accounted for 64% of cases, most frequently flomoxef [a cephalosporin]; only 4 cases were due to amoxicillin-clavulanate). 33987340
Goyal L, Madabhushi AK, Siddiqi MS, Kale S, Mallick DC. severe case of cholestatic hepatitis from amoxicillin/clavulanic acid. Cureus. 2022;14:e25797. (63 year old man developed jaundice 2 weeks after finishing a 14-day course of amoxicillin-clavulanate [bilirubin 29.1 mg/dL, ALT 256 U/L, Alk P 405 U/L] which improved with supportive management). 35812609
Jafry AH, Nimri J, Akhtar KH, Qureshi S, Bray-Hall S. Amoxicillin-clavulanate induced DRESS syndrome masquerading as red man syndrome. J Family Med Prim Care. 2022;11:3992-3995. (32 year old man with bacterial endocarditis developed rash after 10 days of treatment with intravenous vancomycin, ceftriaxone, and metronidazole followed a few days later by fever, lymphadenopathy, eosinophilia, and liver test abnormalities [ALT 514 U/L, Alk P and bilirubin not provided], skin biopsy showing evidence of DRESS syndrome which the authors attributed to amoxicillin-clavulanate but was more likely due to vancomycin). 36387629
Björnsson ES, Stephens C, Atallah E, Robles-Diaz M, Alvarez-Alvarez I, Gerbes A, Weber S, et al. A new framework for advancing in drug-induced liver injury research. The Prospective European DILI Registry. Liver Int. 2023;43:115-126. (Initial results from the prospective European multi-national drug-induced liver injury registry [UK, Spain, Germany, Switzerland, Portugal, Iceland] describes 246 cases, the most frequent implicated agents being amoxicillin-clavulanate [12%], flucloxacillin [11%] atorvastatin [8%], nivolumab/ipilimumab [8%], infliximab [5%], nitrofurantoin [4.5%], disulfiram [2%], and ibuprofen [2%], HDS products [7.3%] and with jaundice in 60% and fatal outcome 4%). 35899490
Appiah J, Prasad A, Shah V, Patel V, Fareen N, Marin AC, Cheriyath P. Amoxicillin-clavulanate induced liver injury in a young female. Cureus. 2023 Jan;15):e33445. PMID: 36751178 (22 year old female developed fever and lymphadenopathy while travelling in Hawaii and was treated with amoxicillin-clavulanate and developed rash and jaundice [bilirubin 3.0 rising to 15.6 mg/dL, ALT 311 U/L, Alk P 156 U/L] with biopsy showing an acute hepatitis and resolution after stopping the antibiotic).
Suzuki A, Tillmann H, Williams J, Hauser RG, Frund J, Suzuki M, Prior F, et al. Assessment of the frequency, phenotypes, and outcomes of acute liver injury associated with amoxicillin/ clavulanate in 1.4 million patients in the Veterans Health Administration. Drug Saf. 2023;46:129-143. (Among 1.4 million first exposures to amoxicillin-clavulanate recorded by the Veterans Administration electronic records between 1999 and 2015, 2249 subsequently developed unexplained acute liver injury suggesting and overall incidence of 0.16% or a rate of 1:625 exposed persons). 36547811
Nicoletti P, Dellinger A, Li YJ, Barnhart HX, Chalasani N, Fontana RJ, Odin JA, et al; Drug-Induced Liver Injury Network (DILIN); International Drug-Induced Liver Injury Consortium (iDILIC); Prospective European Drug-Induced Liver Injury (Pro-Euro DILI) Investigators. Identification of reduced ERAP2 expression and a novel HLA allele as components of a risk score for susceptibility to liver injury due to amoxicillin-clavulanate. Gastroenterology. 2023;164:454-466. (Genome and transcriptome wide association studies on 444 patients with liver injury from amoxicillin-clavulanate vs 10,397 controls identified 3 HLA region risk alleles [A*02:01, B*14:01, and DRB1*15:01], and 2 non-HLA risk variants [in ERAP2 and PTPN22]; the combination of all 5 being applicable in a sensitive genetic risk score). 36496055
Gu S, Rajendiran G, Forest K, Tran TC, Denny JC, Larson EA, Wilke RA. Drug-induced liver injury with commonly used antibiotics in the All of Us Research Program. Clin Pharmacol Ther. 2023;114:404-412. (Among patients enrolled in a prospective study of genetics and health who had been exposed to amoxicillin-clavulanate, electronic medical records identified 30 as developing drug-induced liver injury for an estimated rate of 1:1,227 exposed). 37150941
Medina-Cáliz I, Sanabria-Cabrera J, Villanueva-Paz M, Aukštikalnė L, Stephens C, Robles-Díaz M, Pinazo-Bandera JM, et al. Characterization of drug-induced liver injury associated with drug reaction with eosinophilia and systemic symptoms in two prospective DILI registries. Arch Toxicol. 2024;98:303-325. (Among 1437 patients enrolled in the Spanish and Latin American registries of drug-induced liver injury, 53 [3.7%] developed DRESS syndrome, the most common causes were carbamazepine [13%], anti-tuberculous agents [13%], amoxicillin-clavulanate [11%], allopurinol [8%], and lamotrigine [8%]: DRESS arising in 3% of cases of amoxicillin-clavulanate liver injury). 38051367
Eldredge JA, Pittet LF, Gwee A. Incidence of amoxycillin-clavulanic acid associated hepatotoxicity in an Australian children's hospital. J Antimicrob Chemother. 2024;79:589-594.. (Among 374 children treated with oral or intravenous amoxicillin-clavulanate in a referral pediatric center, 49 [13%] had subsequent abnormal liver tests that were above 3 times ULN in only 14 [3.6%] and all were asymptomatic; no mention of bilirubin elevations or exact nature or degree of liver test abnormalities). 38297994
Pinazo-Bandera JM, Niu H, Alvarez-Alvarez I, Medina-Cáliz I, Del Campo-Herrera E, Ortega-Alonso A, Robles-Díaz M, et al. Rechallenge in idiosyncratic drug-induced liver injury: An analysis of cases in two large prospective registries according to existing definitions. Pharmacol Res. 2024;203:107183.. (Among 1418 patients enrolled in the Spanish and Latin American registries on drug-induced liver injury, 58 had a positive rechallenge response which were mostly unintentional and most commonly with amoxicillin-clavulanate [n=10], resulting in a shorter latency, longer time for recovery, and in several instances more severe liver injury, one of which was fatal). 38631619
Meier M, Eriksen PL. Severe hepatic cholestasis after treatment with amoxicillin/clavulanic acid. Ugeskr Laeger. 2024;186:V02240094. Danish. PMID: 38847310. (80 year old woman with chronic obstructive pulmonary disease was treated for a lung infection with amoxicillin-clavulanate for 20 days and developed jaundice 12 days after stopping [bilirubin 13 mg/dL, ALT 449 U/L, Alk P 707 U/L] and remained markedly jaundiced for the next 9 weeks when she “died peacefully at her own home”).
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications including 29 attributed to amoxicillin-clavulanate for an estimated incidence rate of 1 per 1,850 patients per year exposed). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 58 [14%] were attributed to amoxicillin-clavulanate, the single most frequently implicated agent). 38992407
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160. 39317916. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 191 cases [15%] attributed to amoxicillin-clavulanate, the single most frequently implicated drug, occurring at a previously defined rate of 1 per 2,400 persons treated).
Lammert C, Teal E, Ghabril M, Chalasani N. Incidence of possible drug-induced liver injury due to commonly implicated agents in the United States. Clin Gastroenterol Hepatol. 2025;23:1061-1062.e1. 39447947. (Analysis of a health database of 16 Indiana University Health hospitals between 2017 and 2022, identified 54 cases of drug-induced liver injury to commonly implicated agents including 8 attributed to amoxicillin-clavulanate which suggested an incidence rate of 1:3,650 patients exposed).
Björnsson RA, Sigurdsson SS, Arnarson DT, Logason E, Björnsson ES. The frequency of drug-induced liver injury due to antibiotics among hospitalised patients. Drug Saf. 2025;48:795-804.. (Among 2292 patients treated with the 14 most used antibiotics while hospitalized in a single Icelandic referral center between 2012-2023, 52 developed drug-induced liver injury including 16 attributed to amoxicillin-clavulanate for an estimated rate of 1:1,330 patients exposed). 40072769
Rahnama-Moghadam S, Arora N, Vuppalanchi R, Li YJ, Gu J, Barnhart H, Phillips E, Chalasani N; Drug Induced Liver Injury Network. DRESS syndrome in patients with drug-induced liver injury: characteristics and high-risk factors. Am J Gastroenterol. 2025 Jun 12:10. Epub ahead of print.. (Among 2121 patients with suspected drug-induced liver injury enrolled in a prospective US registry between 2004 and 2023, 258 were attributed to amoxicillin-clavulanate including only 3 [1%] with DRESS syndrome, and another 44 [17%] had rash without DRESS). 40504263
Zhan Y, Liao JM, Ye L, Zhang L, Zhang Z, Yin JY. The role of endoplasmic reticulum aminopeptidase ERAP2 pathogenic mutation rs1363907 in amoxicillin clavulanate-induced liver injury: a special case report. Front Pharmacol. 2025;16:1564124. (52 year old Chinese woman with a history of multiple bouts of jaundice and intermittent therapy with amoxicillin-clavulanate presented 10 days after restarting the drug with jaundice [bilirubin 3.3 mg/dL, ALT 778 U/L, Alk P 178 U/L] resolving with medical management and genetic testing demonstrating none of the known risk HLA alleles but the ERAP2 variant associated with the liver injury in Caucasians [but is also found in ~25% of controls]). 40469972
Gallagher JA, Dababneh Y, Gregory A, Ahsan BU, Gonzalez HC. The straw that broke the camel's back: amoxicillin-clavulanate unraveling autoimmune hepatitis in a previously asymptomatic female. Cureus. 2025;17:e91240. (61 year old woman with metabolic syndrome developed jaundice 10 weeks after an 11 day course of amoxicillin-clavulanate [bilirubin 10 mg/dL, ALT 583 U/L, Alk P 267 U/L, ANA 1:640, biopsy showing very active disease and plasma cells] with prolonged injury and response to corticosteroids and mycophenolate with relapses on lowering prednisone dose, interpreted as autoimmune hepatitis triggered by drug-induced liver injury). 41030704
Sigurdarson SS, Bjornsson HK, Snorrason BL, Bjornsson ES. DILI is an important cause of hepatocellular and mixed liver injury-a nationwide prospective study on elevated liver enzymes. Liver Int. 2025;45:e70327.. (Among 818 patients seen at a single referral hospital in Iceland between 2022 and 2024 with an ALT above 500 U/L or an ALT above 250 U/L with a Alk P above 210 U/L, the cause was choledocholithiasis in 42%, ischemic hepatitis in 17%, hepatobiliary cancer in 8%, drug-induced liver injury in 8%, and viral hepatitis in 6%; the most common causes of drug-induced injury were amoxicillin-clavulanate [12 cases], checkpoint inhibitors [8 cases], and green tea [4 cases]). 40905602
Okafor M, Konlack Mekontso JG, Joglekar N, Pandya N, Trillo J. When a budget-friendly drug leads to a premium diagnosis: a case report of severe cholestasis following amoxicillin-clavulanate use. Case Reports Hepatol. 2025;2025:6781220. (69 year old woman developed dark urine followed by jaundice 4 weeks after a course of amoxicillin-clavulanate for sinusitis [bilirubin 5.3 rising to 18.6 mg/dL, ALT 527 U/L, Alk P 229 U/L], resolving in 2-4 months, the diagnosis being delayed because of the long period between taking the drug and onset of liver injury). 41333647
Khadka S, Dev A, Yadav PS, Acharya S, Karki A, Shah L. Rapid-onset drug-induced liver injury following amoxicillin-clavulanate: a case report. Clin Case Rep. 2025;13:e71655. (32 year old Nepalese woman with severe sore throat and fever was treated with amoxicillin-clavulanate and developed worsening fever and jaundice one day later [bilirubin total 4.3, direct 2.5 mg/dL, ALT 36 U/L, Alk P206 U/L] with rapid improvement on stopping and treatment with ceftriaxone and azithromycin). 41368064

## OTHER REFERENCE LINKS

1. Recent References on Amoxicillin-Clavulanate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Augmentin%20OR%20Amoxicillin%20clavulanate/AE+AND+human%5Bmh%5D+AND+(liver+diseases/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+jaundice/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222007/6/15%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Amoxicillin-Clavulanate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Amoxicillin%20clavulanate)